# Phentermine-Topiramate

## OVERVIEW

### Introduction

The fixed combination of phentermine and topiramate has been developed as a weight loss agent and was approved for use in the United States in 2012. This combination has not been linked to serum enzyme elevations or clinically apparent liver injury, but has had limited general use. Topiramate by itself is used as an anticonvulsant and has been implicated in rare instances of acute liver injury.

### Background

Phentermine (fen' ter meen) has been available for many years as an over-the-counter weight loss aid, acting largely by sympathetic stimulation. Topiramate (toe pyre' a mate) was developed as an anticonvulsant, but studies of its efficacy in patients with seizures noted mild weight loss. Because both agents are fairly well tolerated, the combination was studied as an approach to weight loss using lower doses than employed with either as monotherapy. First in small pilot studies and later in sponsored, large randomized controlled trials, these studies showed that fixed combinations of these two agents led to weight loss that was significantly greater than occurred with placebo. The combination of phentermine and topiramate was approved for use in the United States in 2012 as a weight loss agent for patients with obesity (BMI >30) or who are overweight (BMI=27-30) and have an obesity related condition. There is only limited information on general clinical use of the combination. Fixed doses of phentermine (3.75, 7, 11.25 and 15 mg) with topiramate (23, 46, 69 and 92 mg) are available as capsules under the brand name of Qsymia. Common side effects include paresthesias, dizziness, dry mouth, constipation, insomnia and change in taste. Uncommon side effects may include depression, anxiety and nephrolithiasis. Topiramate therapy during pregnancy has been associated with oral cleft defects in newborns and this combination is contraindicated in women of child bearing potential who cannot practice birth control.

### Hepatotoxicity

In premarketing clinical trials, serum aminotransferase elevations were no more common among patients receiving the combination of phentermine and topiramate than placebo. Clinically apparent liver injury due to this combination has not been reported, but several instances of acute liver injury have been linked to topiramate monotherapy of other conditions. Case reports of liver injury attributed to topiramate have occurred largely in patients with seizure disorders who were receiving other anticonvulsants with known hepatotoxic potential. Topiramate is metabolized by the cytochrome P450 system and is known to induce CYP 3A4 activity and alter the levels of other anticonvulsants, thus predisposing to hepatic injury. By itself, topiramate has not been linked to severe hepatic injury.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury).

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been linked to phentermine/topiramate, but it has had limited general clinical use.

References on the hepatotoxicity and safety of phentermine and topiramate separately are given in the sections on the individual agents.

- Phentermine
- Topiramate

Drug Class: Weight Loss Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phentermine-Topiramate – Qsymia®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=40dd5602-53da-45ac-bb4b-15789aba40f9)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phentermine-Topiramate | 960078-81-3 | C12-H21-N-O8-S.C10-H15-N

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999, well before the availability of phentermine/topiramate).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to phentermine or topiramate).
(2011). Diet, drugs and surgery for weight loss. Treat Guidel Med Lett. (Concise review of approved and unapproved medical and surgical approaches to obesity; the sympathomimetic amines are the oldest weight loss drugs, but are approved for short term use only; no mention of hepatotoxicity in discussion of side effects of phentermine).
Gadde KM, Allison DB, Ryan DH, Peterson CA, Troupin B, Schwiers ML, Day WW. (2011). Effects of low-dose, controlled-release, phentermine plus topiramate combination on weight and associated comorbidities in overweight and obese adults (CONQUER): a randomised, placebo-controlled, phase 3 trial. Lancet. (Randomized controlled trial of 56 weeks of two doses of phentermine-topiramate vs placebo in 2487 overweight or obese patients; no mention of ALT levels or hepatotoxicity).
Powell AG, Apovian CM, Aronne LJ. (2012). The combination of phentermine and topiramate is an effective adjunct to diet and lifestyle modification for weight loss and measures of comorbidity in overweight or obese adults with additional metabolic risk factors. Evid Based Med. (Commentary on Gadde [2011] pointing out that this regimen "is more efficacious than anything currently on the market"; no discussion of adverse events).
Lauer MS. (2012). Lemons for obesity. Ann Intern Med. (Editorial criticizing the decision to approve phentermine-topiramate for general use in the US, expressing concerns of potential long term adverse effects which have not been adequately evaluated in premarketing studies).
Garvey WT, Ryan DH, Look M, Gadde KM, Allison DB, Peterson CA, Schwiers M, et al. (2012). Two-year sustained weight loss and metabolic benefits with controlled-release phentermine/topiramate in obese and overweight adults (SEQUEL): a randomized, placebo-controlled, phase 3 extension study. Am J Clin Nutr. (Controlled extension to two years of a randomized controlled trial of phentermine-topiramate vs placebo in 676 obese patients; weight loss was sustained and common side effects were similar with longer therapy: "No dose related changes were observed in shift summaries of selected laboratory values").
Allison DB, Gadde KM, Garvey WT, Peterson CA, Schwiers ML, Najarian T, Tam PY, et al. (2012). Controlled-release phentermine/topiramate in severely obese adults: a randomized controlled trial (EQUIP). Obesity (Silver Spring). (Randomized controlled trial of two dose regimens of phentermine-topiramate vs placebo in 1267 obese subjects; common side effects were paresthesias, dry mouth, constipation, headache, change in taste, insomnia and depression; no mention of ALT levels or hepatotoxicity).
Kang JG, Park CY. (2012). Anti-Obesity Drugs: A Review about Their Effects and Safety. Diabetes Metab J. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that phentermine has been available for 50 years, but there is little data on its long term efficacy and safety).
(2012). 2 new drugs for weight loss. Med Lett Drugs Ther. (Concise review of phentermine-topiramate and lorcaserin for weight loss shortly after their approval for use in the US; in discussion of side effects, no mention of hepatotoxicity).
Smith SM, Meyer M, Trinkley KE. (2013). Phentermine/topiramate for the treatment of obesity. Ann Pharmacother. (Review of the pharmacology, efficacy and safety of phentermine/topiramate focusing on 3 phase 3 trials which found a dose related effect on weight loss that was sustained for over 2 years while adverse events included paresthesia, dizziness, dysgeusia, insomnia, constipation and dry mouth; no mention of ALT elevations or hepatotoxicity, although recommended caution and monitoring in patients with preexisting liver disease).
Kim HO, Lee JA, Suh HW, Kim YS, Kim BS, Ahn ES, Roh YJ, et al. (2013). Postmarketing surveillance study of the efficacy and safety of phentermine in patients with obesity. Korean J Fam Med. (Among 795 obese Korean patients enrolled in a prospective surveillance program and treated with phentermine [37.5 mg daily], the mean weight loss at 12 weeks was 3.8 kg and 30% of patients reported adverse events, but none were serious and there was no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (Population based prospective analysis of cases of drug induced liver injury seen over a two year period in Iceland identified 96 cases, none of which were attributed to weight loss agents).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, none of which were attributed to phentermine or topiramate, separately or together).
Yanovski SZ, Yanovski JA. (2014). Long-term drug treatment for obesity: a systematic and clinical review. JAMA. (Systematic review of the literature on the efficacy of long term use of drugs for obesity that were FDA approved [at the time of the analysis] mentions that phentermine, diethylpropion and phendimetrazine are approved for short term use only, but that orlistat, lorcaserin and phentermine/topiramate are approved for long term use although their efficacy is modest; no discussion of hepatotoxicity).
Hainer V, Aldhoon-Hainerová I. (2014). Tolerability and safety of the new anti-obesity medications. Drug Saf. (Review of the safety of two recently approved [2012] drugs for obesity [phentermine/topiramate and lorcaserin] based upon large, randomized controlled trials mentions that adverse events were common but usually mild-to-moderate in severity and decreasing with continued usage beyond 1 year; no mention of ALT elevations or hepatotoxicity).
Alfaris N, Minnick AM, Hopkins CM, Berkowitz RI, Wadden TA. (2015). Combination phentermine and topiramate extended release in the management of obesity. Expert Opin Pharmacother. (Review of the history of development, chemistry, mechanism of action, clinical efficacy and safety of phentermine/topiramate in the management of obesity, discusses the common adverse events and the special concerns regarding heart rate, depression, and fetal abnormalities associated with long term use, but no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two cases were attributed to topiramate separately and not as a combination and another unlikely case was attributed to phentermine given by itself).
Aagaard L, Hallgreen CE, Hansen EH. (2016). Serious adverse events reported for antiobesity medicines: postmarketing experiences from the EU adverse event reporting system EudraVigilance. Int J Obes (Lond). (Analysis of adverse event reports from antiobesity medications to the European pharmacovigilance database [EudraVigilance] between 2007 and 2013 identified 4941 reports detailing 13,957 individual adverse events, 90% serious, only 15 attributed to phentermine with 2 deaths, but none were classified as hepatobiliary).
Halpern B, Mancini MC. (2017). Safety assessment of combination therapies in the treatment of obesity: focus on naltrexone/ bupropion extended release and phentermine-topiramate extended release. Expert Opin Drug Saf. (Review of the mechanism of action, clinical efficacy and safety of fixed combination therapies for obesity discusses the common adverse events of phentermine/topiramate as well as psychiatric, cardiovascular, renal, ophthalmologic and pregnancy-fetal toxicity, but discussion of hepatic safety is limited to the issue of increased drug levels in patients with hepatic impairment).
(2018). Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther. (Concise review of the medical and surgical therapies for obesity mentions that for orlistat “severe liver injury has been reported rarely, but no cause-and-effect relationship has been established”; discussions of adverse events due to other weight loss agents [phentermine/ topiramate, naltrexone/bupropion, lorcaserin and liraglutide] do not mention ALT elevations or hepatotoxicity).
Saunders KH, Umashanker D, Igel LI, Kumar RB, Aronne LJ. (2018). Obesity pharmacotherapy. Med Clin North Am. (Review of the pharmacotherapy of obesity focusing upon the 6 most commonly used medications, discusses the common side effects of phentermine/topiramate, but does not discuss hepatotoxicity).
Patel DK, Stanford FC. (2018). Safety and tolerability of new-generation anti-obesity medications: a narrative review. Postgrad Med. (Review of the history of approval and indications, efficacy and long term safety of major currently available weight loss agents including orlistat, phentermine/topiramate, lorcaserin, liraglutide and naltrexone/bupropion; does not discuss hepatotoxicity).
Lewis KH, Fischer H, Ard J, Barton L, Bessesen DH, Daley MF, Desai J, et al. (2019). Safety and effectiveness of longer-term phentermine use: clinical outcomes from an Electronic Health Record Cohort. Obesity (Silver Spring). (Among 13,972 adults who initiated therapy with phentermine between 2010-15 identified by electronic health records, those who remained on long term therapy [n=144] lost an average of 7.5% of weight vs none of those in follow up after short term therapy, and there were no differences in composite adverse cardiovascular outcomes with long term continuous or intermittent therapy; no mention of hepatotoxicity or ALT elevations).
Safer DL, Adler S, Dalai SS, Bentley JP, Toyama H, Pajarito S, Najarian T. (2020). A randomized, placebo-controlled crossover trial of phentermine-topiramate ER in patients with binge-eating disorder and bulimia nervosa. Int J Eat Disord. (Among 22 adults with binge eating disorder or bulimia treated with phentermine-topiramate [escalating dose to 15/92 mg] or placebo for 12 weeks followed by wash-out and cross over, weight loss was -5.8 kg on drug vs +0.4 kg on placebo; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
Hsia DS, Gosselin NH, Williams J, Farhat N, Marier JF, Shih W, Peterson C, et al. (2020). A randomized, double-blind, placebo-controlled, pharmacokinetic and pharmacodynamic study of a fixed-dose combination of phentermine/topiramate in adolescents with obesity. Diabetes Obes Metab. (Among 42 obese adolescents treated with phentermine/topiramate [7.5/46 mg or 15/92 mg] or placebo once daily for 56 days, weight loss of at least 5% was achieved in 13% and 50% on the drug combination vs none on placebo and side effects were usually mild, 2 patients stopped drug early because of adverse events; no mention of ALT elevations or hepatotoxicity).
Tak YJ, Lee SY. (2020). Anti-obesity drugs: long-term efficacy and safety: an updated review. World J Mens Health. (Review of currently available agents for long term therapy of obesity with specific discussion of mechanism of action, dosing regimen, efficacy and safety, mentions that phentermine/topiramate has the highest rates of weight loss compared to other agents, but also has a high rate of discontinuation because of side effects such as insomnia, paresthesia, dizziness, dry mouth, dysgeusia and constipation and has embryo-fetal toxicity; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Phentermine-Topiramate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Qsymia/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Phentermine-Topiramate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Qsymia)